# Arsenic

## OVERVIEW

### Introduction

Arsenic is a nonessential trace element that is widely distributed in nature. Arsenic was used in medicinal agents in the 19th and early 20th centuries, but has been replaced by safer and more effective agents and has not been in use for over 50 years. Nevertheless, arsenic is found widely in nature and accidental or intentional acute or chronic exposures to moderate or high levels of arsenic can cause liver injury, sometimes presenting long after the exposure.

### Background

Arsenic is a nonessential trace element and well known poison that is found widely in low concentrations in the environment. Typical arsenic concentrations are 2 to 5 parts per billion in soil and sea water. In the United States, the maximal allowable concentration of arsenic in well and drinking water is 50 parts per billion. Arsenic is used in pesticides and herbicides and is a byproduct of the mining of other metals, such as copper and lead. Arsenic can also contaminate herbal preparations and dietary supplements. As a consequence, occupational or accidental exposure to moderate or high doses of arsenic can occur, but are fortunately rare, at least in the United States and most of the developed world. Arsenic was formerly used medically as Fowler's solution (1% arsenic trioxide) to treat inflammatory conditions such as asthma, psoriasis and leukemia, and as various organic arsenicals such as arsphenamine (Salvarsan), mapharsen and tryparsamide to treat syphilis and protozoal infections. These agents are no longer used and have been replaced by more effective and safer agents. Arsenic is still a component of some traditional and herbal preparations and is still used to treat acute promyelocytic leukemia under the brand name Trisenox (arsenic trioxide) in intravenous doses of 10 mg daily for up to 60 days, followed by different dosing in consolidation and maintenance regimens.

### Hepatotoxicity

Acute poisoning with arsenic is marked by severe abdominal pain, nausea and vomiting, diarrhea, muscle cramps, metallic taste and extreme thirst, followed by stupor, coma, cardiovascular collapse and death. Death can occur within 24 hours of exposure, but with sublethal doses, survival is possible and liver injury may arise 24 to 48 hours after the acute ingestion. Other symptoms include conjunctival and respiratory tract inflammation, epistaxis, rash, renal insufficiency and painful neuropathy. The characteristics of the liver injury have not been well defined, but are likely similar to those with acute iron poisoning, with a clinical phenotype of acute hepatic necrosis, marked elevations in serum aminotransferase levels, early onset of hepatic failure and rapid recovery in cases without early fatality.

Chronic, lower dose exposure to arsenic can be toxic and result in arsenosis, a syndrome marked by fatigue, nausea and vomiting, abdominal crampy pain, weakness, stupor, seizures and neuropathy. Skin manifestations are frequent and characteristic with chronic excessive exposure marked by hyper- and hypo-pigmentation, a "rain-drop" pattern of skin discoloration, skin dryness and exfoliation, keratosis of the palms and soles, and skin cancers. Arsenic is also deposited in the hair and nails, where it can be detected even after it is no longer measureable in urine. Liver injury can also occur with chronic arsenic exposure, typically with appearance of signs and symptoms of portal hypertension, without obvious cirrhosis (idiopathic or noncirrhotic portal hypertension). The clinical onset of noncirrhotic portal hypertension is often insidious with weight loss, fatigue and abdominal swelling and minor, nonspecific elevations in serum enzymes, followed by appearance of variceal hemorrhage or ascites. Features of portal hypertension (ascites, variceal hemorrhage) rather than hepatic failure (jaundice, encephalopathy or coagulopathy) predominate. Symptoms generally improve slowly upon withdrawal of arsenic exposure and long term survival is not uncommon, although porto-caval shunting may be needed to manage portal hypertension and variceal hemorrhage. Serum enzyme elevations and jaundice are uncommon, but may occur. Chronic exposure is usually due to environmental contamination, from elevated arsenic levels in water due to run-offs from mining or storage of arsenic containing compounds such as herbicides and pesticides. When arsenic was still being used as a medicinal agent, cases of chronic poisoning were linked to use of Fowler's solution for psoriasis and asthma and arsphenamine for syphilis generally after 5 to 25 years of use. Furthermore, some cases became clinically apparent several years after the arsenical was stopped and at a time that arsenic could no longer be detected in urine, tissue or hair samples. Chronic arsenic exposure has also been linked to cirrhosis, although the contribution of alcohol and other chronic liver diseases in reported cases could not be excluded. Chronic exposure has also been linked to liver cancer, including hepatic angiosarcoma and hepatocellular carcinoma. Other long term complications of arsenic exposure include skin discoloration, palmar and plantar keratosis, peripheral neuropathy, and skin and lung cancer which can arise several decades after exposure. Patients presenting with noncirrhotic portal hypertension due to arsenic frequently have other manifestations of its chronic toxicity such as skin discoloration, palmar keratosis and skin cancers.

Arsenic trioxide (Trisenox) given intravenously as therapy of acute promyelocytic leukemia has had limited use, but hepatotoxicity has been reported in 8% to 47% of patients, generally in the form of mild and transient serum enzyme elevations that resolve even with continuation of treatment. Nevertheless, more severe hepatic injury has been reported including cases of acute liver failure, although the clinical features of the injury and relatedness to the therapy were not well defined.

Likelihood score: A[HD] (well known cause of chronic liver injury when given in high dosess).

### Mechanism of Injury

Arsenic uncouples oxidative phosphorylation and is a general cytoplasmic toxin binding to and inhibiting sulfhydryl groups on essential enzymes. With acute exposures, the skin, cardiac and neurologic toxicities are most prominent. With chronic exposure, skin and hepatic manifestations may dominant the clinical picture.

### Outcome and Management

Arsenic poisoning is often treated with chelation, with uncertain efficacy. Both dimercaprol and succimer have been used, but their efficacy in ameliorating symptoms and signs and speeding clinical recovery has not been documented. The major invention should be directed at detection and elimination of the source of arsenic contamination and identification of others who might be exposed in the same manner.

Drug Class: Trace Elements and Metals

## CASE REPORT

### Case 1. Noncirrhotic portal hypertension attributed to arsenic exposure.

[Modified from: Upshaw CB Jr, Bryant MF, Claiborne TS Jr. Noncirrhotic portal hypertension after arsenic ingestion. South Med J 1979; 72: 1332-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/482995); Upshaw CB Jr, Claiborne TS Jr. Medicinal arsenic poisoning: 27-year follow-up. South Med J 1995; 88: 892-3. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/7631226)]

A 45 year old man developed recurrent variceal hemorrhage having taken an arsenic containing preparation for 2 years, several years in the past. He denied a history of liver disease, jaundice, alcohol abuse or risk factors for viral hepatitis. Several years in the past he had developed asthma and was treated with Fowler's solution (1% arsenic trioxide) for two years, between the ages of 40 and 42. The estimated total dose of arsenic was 1.6 grams. Thereafter, he felt well until he began developing episodes of hematemesis and melena approximately 3 years later. On examination, he appeared healthy but pale. A spleen tip was felt in the left upper quadrant, but there was no hepatomegaly, jaundice, ascites, peripheral edema, wasting or spider angiomata. Laboratory testing showed a hematocrit of 34%, white blood count 2,700/µL and platelet count 70,000/µL, but routine liver tests were normal. Gastrointestinal radiology showed esophageal varices and splenomegaly. A splenoportogram showed an elevated splenic pulp pressure [29 mm Hg, normal 3-17], but no evidence of splenic or portal vein thrombosis. He underwent splenectomy and anastomosis of the splenic vein to the left renal vein, which normalized the elevated portal pressure. He recovered from surgery uneventfully and had no further gastrointestinal bleeding or symptoms of liver disease, but had mildly abnormal liver test results (AST and Alk P < twice ULN) and an abnormal liver-spleen scan. He also developed several skin carcinomas, but died as a result of a farm accident 27 years after initial presentation and surgery.

#### Key Points

Medication: | Arsenic trioxide (1% solution) for 2 years
Pattern: | None: normal serum enzymes
Severity: | 4+, variceal hemorrhage
Latency: | 4 years after a 2 year course of treatment
Recovery: | Symptomatically complete
Other medications: | None mentioned

#### Comment

This case was distinctive in having excellent long term follow up summarized in a subsequent letter to the editor by the authors, 16 years after the first report. Noncirrhotic portal hypertension generally arises as a result of chronic injury, probably to portal venules and arterioles as a result of direct toxic endothelial cell injury caused by the high levels of orally absorbed arsenic in the portal system. The usual markers of liver injury are generally absent, serum enzymes being normal or near normal in the majority of patients before and at the time of initial presentation. In addition, the clinical presentation may be months or years after portal hypertension has developed. The most sensitive marker for the progressive increase in portal pressure is a decline in platelet count, even when in the normal range. Strikingly, arsenic may no longer be detectable in plasma, urine, tissue or hair when the liver injury finally becomes clinically manifest. In this case, as in most instances, withdrawal of the arsenic exposure, conservative management and portal decompression, if needed, is generally effective in resolving the clinical complications. The long term prognosis is often dependent upon the other long term complications of arsenic exposure, including skin, liver and lung carcinoma.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Arsenic – Trisenox®

DRUG CLASS

Trace Elements and Metals

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=fluoxetine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Arsenic Trioxide | 1327-53-3 | As2-O3 | Image of Arsenic Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2017

Zimmerman HJ. Arsenic. Environmental hepatotoxicity. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p 420. (Review of hepatotoxicity published in 1999 mentions that exposure to inorganic arsenic and organic arsenicals has been linked convincingly to cases of noncirrhotic portal hypertension and angiosarcoma, but somewhat less well to cirrhosis and hepatocellular carcinoma).
Toman KG, Dalpiaz AS. Arsensic. Occupational and environmental hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p 670. (Textbook on hepatotoxicity; mentions high incidence of cirrhosis in vineyard workers, coal miners and farmers exposed to arsenic and multiple reports of hepatoportal sclerosis, liver cancer and hepatic angiosarcoma, with water and environmental exposure to excessive concentrations of arsenic).
Byrns MC, Penning TM. Treatment of metal exposure. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1872-6. (Textbook of pharmacology and therapeutics).
Hathcock JN, Rader JI. Arsenic. Food additives, contaminants, and natural toxins. In, Shils ME, Olson JA, Shihe M, Ross AC, eds. Modern Nutrition in Health and Disease. 9th ed. Baltimore: Williams & Wilkins, 1999, pp. 1866-7. (Textbook of nutrition).
Bang FL. [Hydrops due to arsenic ingestion]. Soc Med Havn Collect 1884; 1: 307-9. Not in PubMed. (Initial report of anasarca associated with chronic use of arsenicals, quoted in O'Leary et al. 1928).
Geyer L. Arch F Dermat u Syph 1898; 43: 221. Not in PubMed. (Quoted in Franklin [1950]; patient developed anasarca and ascites while on medicinal arsenic).
Hamburger LP. Bull John Hopkins Hosp 1900; 11: 87. Not in PubMed. (Quoted in Franklin [1950]; patient developed anasarca and ascites while on medicinal arsenic).
Hutchinson J. Arch Surg 1895; 6: 380. Not in PubMed. (Quoted in Franklin [1950]; patient developed skin discoloration, keratosis and ascites while on medicinal arsenic).
Reynolds ES. An account of the epidemic outbreak of arsenical poisoning occurring in beer-drinkers in the north of England and the Midland counties in 1900. Lancet 1901; 157 (4038): 166-70. Not in PubMed. (A large number of cases of suspected alcoholic neuritis with skin eruptions and keratosis occurring in Manchester, England in 1900 were found to be due to arsenic poisoning from contamination of inexpensive beer [perhaps by sulfuric acid used in its manufacture], most patients presenting with neuropathy, but some with ascites and suspected cirrhosis).
Sturroch AC, Brown J, Bowser JE, Infield S. Epidemic of peripheral neuritis traced to arsenical contamination of beer-making materials. Brit Med J 1900; 2: 1815-6. Not in PubMed. (An epidemic of painful peripheral neuropathy was traced to inexpensive beer drinking, possibly due to contamination in added sugar; 8 patients also presented with an "interstitial hepatitis" marked by abdominal pain, hepatomegaly and ascites sometimes with mild jaundice, resolving rapidly upon stopping beer intake).
O'Leary PA, Snell AM, Bannick EG. Portal cirrhosis associated with chronic inorganic arsenical poisoning. JAMA 1928; 90: 1856-9. Not in PubMed. (Two cases and review of literature; 52 year old man developed abdominal distention 4 years after starting a solution of potassium arsenite for dermatitis herpetiformis, with normal serum bilirubin despite massive ascites and slow improvement with stopping; 41 year old man developed ascites and skin pigmentation a year after starting potassium arsenite with normal serum bilirubin [0.5 mg/dl] and slow improvement on stopping arsenic).
Weir JF. Cirrhosis associated with chronic inorganic arsenical poisoning. Mayo Clin Pro 1930; 5: 173. Not in PubMed. (Two cases: 43 year old woman with pruritus, hyperpigmentation and jaundice [bilirubin 3.4 mg/dL] who developed ascites and variceal hemorrhage and had arsenic found in urine, but no mention of source; 27 year old woman with pruritus, hyperpigmentation and jaundice [bilirubin 7.8 mg/dL] suspected to be on Fowler's solution; but neither case had histologic confirmation of cirrhosis and may have represented other forms of liver disease).
Franklin M, Bean WB, Hardin RC. Fowler's solution as an etiologic agent in cirrhosis. Am J Med Sci 1950; 219: 589-96. (Three cases of arsenical dermatitis and cirrhosis in 56-57 year old Iowan farmers who developed evidence of cirrhosis [ascites, variceal hemorrhage, mild jaundice], 2-9 years after starting Fowler's solution of 1% arsenic trioxide, with little evidence of improvement after stopping and no hepatic histology). 15419170
Wade HJ, Frazer ES. Toxipathic hepatitis due to Fowler's solution; a case treated with dimercaprol. Lancet 1953; 1 (6754): 269-71. (40 year old man developed fatigue 16 months after starting Fowler's solution for dermatitis herpetiformis with skin pigmentation and ascites, and was treated with dimercaprol with excellent response). 13012048
Roth F. [Chronic arsenic poisoning of Moselle vineyard-workers, with special reference to arsenic cancer]. Z Krebsforsch 1956; 61 (3): 287-319. German. 13401997
Roth F. [After-effects of chronic arsenism in Moselle wine makers]. Dtsch Med Wochenschr. 1957; 82: 211-7. German. (Analysis of late effects of use of arsenic in pesticides in German vineyards from 1925 to 1942, including cirrhosis and lung cancer). 13414511
Dinman BD. Arsenic: chronic human intoxication. J Occup Med 1960; 2: 137-141.
Shandon S, Sherlock S. Portal hypertension in the myeloproliferative syndrome and the reticuloses. Am J Med 1962; 32: 758-64. (Description of 6 patients with a myeloproliferative disorder presenting with evidence of portal hypertension, 3 having portal thrombosis and 3 unexplained, liver tests being normal except for mild Alk P elevations). 13911166
Mikkelsen WP, Edmondson HA, Peters RL, Redeker AG, Reynolds TB. Extra- and intrahepatic portal hypertension without cirrhosis(hepatoportal sclerosis). Ann Surg 1965; 162: 602-20. (Description of 36 patients with idiopathic portal hypertension without cirrhosis presenting with variceal hemorrhage or ascites and normal or near normal liver histology, some with portal vein obstruction and some not, but with time the liver became shrunken in some patients; the authors termed this syndrome "hepatoportal sclerosis"). 5833586
Sherlock S, Feldman CA, Moran B, Scheuer PJ. Partial nodular transformation of the liver with portal hypertension. Am J Med 1966; 40: 195-203. (Description of 4 cases of noncirrhotic portal hypertension which they called "partial nodular transformation" marked by variceal hemorrhage and ascites, but relatively normal liver function and minimally abnormal liver tests, histology showing nodular formation without much fibrosis). 5948135
Williams R. Portal hypertension in idiopathic tropical splenomegaly. Lancet 1966; 1 (7433): 329-33. (Portal hypertension was found in the majority of patients with idiopathic splenomegaly, some but not all of which appeared to be due to increased portal blood flow). 4159474
Boyer JL, Sen Gupta KP, Biswas SK, Pal NC, Basu Mallick KC, Iber FL, Basu AK. Idiopathic portal hypertension. Comparison with the portal hypertension of cirrhosis and extrahepatic portal vein obstruction. Ann Intern Med 1967; 66: 41-68. (Description of 21 patients with noncirrhotic portal hypertension, frequent finding being intrahepatic portal vein sclerosis). 6015813
Regelson W, Kim U, Ospina J, Holland JF. Hemangioendothelial sarcoma of liver from chronic arsenic intoxication by Fowler's solution. Cancer 1968 Mar; 21 (3): 514-22. (49 year old with psoriasis developed fatigue, jaundice and edema 7 years after stopping Fowler's solution which he had taken off-and-on for 17 years, histology showing hemangioendothelial sarcoma of the liver [hepatic angiosarcoma]). 5688987
Regelson W, Kim U, Ospina J, Holland JF. Hemangioendothelial sarcoma of liver from chronic arsenic intoxication by Fowler's solution. Cancer 1968; 21: 514-22. (49 year old man had taken Fowler's solution for 17 years for psoriasis and developed jaundice and ascites, dying 2 months later and autopsy showing massive invasion by neoplastic endothelial sarcoma cells). 5688987
Iber FL. Obliterative portal venopathy of the liver and "idiopathic portal hypertension". Ann Intern Med 1969; 71: 660-1. (Editorial on idiopathic portal hypertension and the possible role of obliterative venopathy). 5809690
Tandon BN, Lakshminarayanan R, Bhargava S, Nayak NC, Sama SK. Ultrastructure of the liver in non-cirrhotic portal fibrosis with portal hypertension. Gut 1970; 11: 905-10. (Results of electron microscopy done on 9 cases of idiopathic portal hypertension found normal hepatic cytoplasm and nuclei, but somewhat increase in collagen in widened spaces of Disse). 5492248
Zeegen R, Stansfeld AG, Dawson AM, Hunt AH. Prolonged survival after portal decompression of patients with non-cirrhotic intrahepatic portal hypertension. Gut 1970; 11: 610-7. (Among 251 patients undergoing portacaval shunting, 25% did not have cirrhosis, many of whom had only minor changes in hepatic architecture; these patients had better survival [83% at 5 years] than those with cirrhosis [46%]). 5452049
Sama SK, Bhargava S, Nath NG, Talwar JR, Nayak NC, Tandon BN, Wig KL. Noncirrhotic portal fibrosis. Am J Med 1971; 51: 160-9. (Among 300 cases of portal hypertension studied at a referral center in India, 25% had neither cirrhosis nor portal thrombosis and presented with splenomegaly and variceal hemorrhage or ascites, but with minimal hepatic dysfunction; the liver showing some degree of nodularity, mild fibrosis, inconspicuous small portal veins and thickening of walls of medium sized portal veins). 5315322
Chronic arsenical poisoning and non-cirrhotic portal hypertension – a case for diagnosis. BMJ 1971; 4 (5789): 725-31. (67 year old woman had taken arsenicals for psoriasis for several years in her 20s and developed recurrent variceal hemorrhage in her 50s and later severe hematemesis, ascites and hepatic encephalopathy [bilirubin 1.1 mg/dL, Alk P 13 KA Units], resulting in death at age 67; autopsy showed varices, portal vein thrombosis, but no cirrhosis or signs of regeneration). 5129618
Louria DB, Joselow MM, Browder AA. The human toxicity of certain trace elements. Ann Intern Med 1972; 76: 307-19. (Review of toxicity of trace elements including cobalt, copper, manganese, copper, molybdenum, vanadium selenium, nickel, arsenic, cadmium, tellurium and tin; no discussion of liver injury, cirrhosis or liver cancer). 4550590
Feinglass EJ. Arsenic intoxication from well water in the United States. N Engl J Med 1973; 288: 828-30. (Among 13 workers exposed to arsenic from well water [21,000 parts per billion] over a 10 week period, 11 developed symptoms of nausea and vomiting, abdomen pain or diarrhea and 2 had neuropathy). 4348410
Knolle J, Föer E, Roessner A, Themann H, HöP, Meyer zum Büfelde KH. [Non-cirrhotic portal fibrosis(hepatoportal sclerosis) after chronic arsenic poisoning: clinical and morbid-anatomical findings (author's transl)]. Dtsch Med Wochenschr 1974; 99: 903-8. German. (40 year old man had esophageal variceal hemorrhage from noncirrhotic portal hypertension attributed to a five year course of organic arsenicals for psoriasis 10 years previously). 4546042
Morris JS, Schmid M, Newman S, Scheuer PJ, Sherlock S. Arsenic and noncirrhotic portal hypertension. Gastroenterology 1974; 66: 86-94. (Two patients with portal hypertension and variceal hemorrhage with minimal portal fibrosis had been treated with Fowler's solution for psoriasis for 3 and 22 years, and also suffered with skin pigmentation, skin cancers, keratosis and laryngeal and bronchial carcinomas). 4809505
Wilkinson SP, McHugh P, Horsley S, Tubbs H, Lewis M, Thould A, Winterton M, et al. Arsine toxicity aboard the Asiafreighter. Br Med J 1975; 3 (5983): 559-63. (Four sailors were exposed to arsenous hydride gas, which had leaked from a metal cylinder during a storm at sea, and developed severe fever, headache, muscle and abdominal pains, nausea and vomiting followed by dyspnea, intravascular hemolysis, renal failure and stupor or coma; all had tender hepatomegaly, but liver tests were mostly normal and all recovered). 169942
Huet PM, Guillaume E, Cote J, Léré, Lavoie P, Viallet A. Noncirrhotic presinusoidal portal hypertension associated with chronic arsenical intoxication. Gastroenterology 1975; 68 (5 Pt 1): 1270-7. (39 year old man developed noncirrhotic portal hypertension, having received organic arsenicals for psoriasis for 12 years, presenting with splenomegaly and variceal hemorrhage without hepatomegaly or abnormal liver tests). 1126603
Lander JJ, Stanley RJ, Sumner HW, Boswell DC, Aach RD. Angiosarcoma of the liver associated with Fowler's solution (potassium arsenite). Gastroenterology 1975 Jun; 68(6): 1582-6. (43 year old man with psoriasis developed variceal hemorrhage 6 years after taking Fowler's solution for 15 years, with hyperkeratosis, on soles and palms, hyperpigmentation, hepatomegaly [bilirubin 1.3 mg/dL, AST 87 U/L, Alk P 332 U/L] with large hepatic angiosarcoma, but normal appearing surrounding nontumorous liver tissue). 1169181
Villeneuve JP, Huet PM, Joly JG, Marleau D, CôJ, Léré, Lafortune M, et al. Idiopathic portal hypertension. Am J Med 1976; 61: 459-64. (Five cases of idiopathic portal hypertension presenting with variceal hemorrhage, but without cirrhosis, including one attributed to chronic arsenic exposure). 1086057
Datta DV. Letter: Arsenic and non-cirrhotic portal hypertension. Lancet 1976; 1 (7956): 433. (Arsenic levels were high in the liver of a patient with arsenic related noncirrhotic portal hypertension [247 vs 10 µg/100 g], but were also elevated in kidney, brain, intestine and heart). 55707
Hine CH, Pinto SS, Nelson KW. Medical problems associated with arsenic exposure. J Occup Med 1977; 19: 391-6 (Monitoring of employees in a large smeltering plant found little evidence of arsenic toxicity, AST elevations in 2.3%, but seemingly unrelated to the exposure). 141494
Pimentel JC, Menezes AP. Liver disease in vineyard sprayers. Gastroenterology 1977; 72: 275-83. (Histologic description of livers from 30 vineyard sprayers' exposed chronically to high levels of copper, found copper granules in Kupffer cells in all 30, with granulomas, fibrosis [portal], nodular regeneration ["liver function was usually normal"] angiosarcoma, cirrhosis and NCPH, although the rates of these findings were not given). 556610
Ulmer DD. Trace elements. N Engl J Med 1977; 297: 318-21. (Brief review of trace elements, their metabolic roles, deficiencies and toxicities). 876314
Popper H, Thomas LB, Telles NC, Falk H, Selikoff IJ. Development of hepatic angiosarcoma in man induced by vinyl chloride, thorotrast, and arsenic. Comparison with cases of unknown etiology. Am J Pathol 1978; 92: 349-76. (Review of the histologic features of hepatic angiosarcoma of varying causes indicated a commonality of early changes, suggesting shared pathogenesis in those cases of unknown cause). 567014
Axelson O, Dahlgren E, Jansson CD, Rehnlund SO. Arsenic exposure and mortality: a case-referent study from a Swedish copper smelter. Br J Ind Med 1978; 35: 8-15. (Case control study of causes of death among Swedish copper smelters with different levels of arsenic exposure suggested an increased rate of lung cancer and cardiovascular disease and a slight increase in cirrhosis). 629894
Datta DV, Mitra SK, Chhuttani PN, Chakravarti RN. Chronic oral arsenic intoxication as a possible aetiological factor in idiopathic portal hypertension (non-cirrhotic portal fibrosis) in India. Gut 1979; 20: 378-84. (Analysis of liver tissue from 9 patients with non-cirrhotic portal hypertension found elevated arsenic levels in 4 which was linked to increased concentrations in drinking water and perhaps to arsenic contamination of Ayurvedic medications). 468068
Cowlishaw JL, Pollard EJ, Cowen AE, Powell LW. Liver disease associated with chronic arsenic ingestion. Aust N Z J Med 1979; 9:310-3. (Two cases; 64 and 45 year old men with 12 and 10 years of arsenic therapy developed variceal hemorrhage, biopsies showing hepatocellular carcinoma in one and mild fibrosis, but no cirrhosis in the other). 223536
Chainuvati T, Viranuvatti V. Idiopathic portal hypertension and chronic arsenic poisoning. Report of a case. Dig Dis Sci 1979; 24: 70-3. (28 year old Thai woman with psoriasis on long term arsenicals developed variceal bleed and non-cirrhotic portal hypertension [bilirubin 1.0 mg/dL, AST 27, Alk P normal] and underwent splenorenal shunt with excellent outcome). 154997
Szuler IM, Williams CN, Hindmarsh JT, Park-Dincsoy H. Massive variceal hemorrhage secondary to presinusoidal portal hypertension due to arsenic poisoning. Can Med Assoc J 1979; 120: 168-71. (64 year old Canadian man developed variceal bleed having taken an over-the-counter arsenical for 55 years [bilirubin, AST and Alk P normal] and underwent splenorenal shunt with excellent outcome: "Overseas Asthma Relief"). 310707
Upshaw CB Jr, Bryant MF, Claiborne TS Jr. Noncirrhotic portal hypertension after arsenic ingestion. South Med J 1979; 72: 1332-4. (46 year old man developed non-cirrhotic portal hypertension 3 years after finishing a 2 year course of Fowler's solution [liver tests normal], with resolution of bleeding episodes after splenectomy and splenic-renal vein anastomosis: Case 1). 482995
Falk H, Herbert J, Crowley S, Ishak KG, Thomas LB, Popper H, Caldwell GG. Epidemiology of hepatic angiosarcoma in the United States: 1964-1974. Environ Health Perspect 1981; 51: 107-13. (Survey of hepatic angiosarcoma in the United States between 1964 and 1974 found 168 cases, male predominance, peak age 50-59 years, 25% due to known environmental cause [vinyl chloride in 12, arsenic in 6, anabolic steroids in 4 and thorotrast in 20]). 7199426
Falk H, Caldwell GG, Ishak KG, Thomas LB, Popper H. Arsenic-related hepatic angiosarcoma. Am J Ind Med 1981; 2: 43-50. (In a nationwide survey, 7 cases of hepatic angiosarcoma attributable to arsenic exposure were identified between 1964-1974, including 5 who were treated with Fowler's solution for 9-29 years, generally for asthma or psoriasis). 6891179
Falk H, Herbert JT, Edmonds L, Heath CW Jr, Thomas LB, Popper H. Review of four cases of childhood hepatic angiosarcoma--elevated environmental arsenic exposure in one case. Cancer 1981; 47: 382-91. (Review of 4 cases of hepatic angiosarcoma occurring in infants, ages 1-30 months, which had histologic features distinct from those in adults, one case attributed to arsenic exposure and three idiopathic). 7193080
Datta DV, Narang AP, Sahni MM, Banerjee CK, Walia BN. Role of arsenic and copper in the pathogenesis of Indian childhood cirrhosis. Indian Pediatr 1981; 18: 53-7. (Hepatic arsenic levels were elevated in 11 and copper in 15 of 19 children with Indian Childhood Cirrhosis, levels also being elevated in several Ayurvedic medicines used by mothers of the children during the first trimester of pregnancy). 7262995
Roat JW, Wald A, Mendelow H, Pataki KI. Hepatic angiosarcoma associated with short-term arsenic ingestion. Am J Med 1982; 73: 933-6. (45 year old man, who had taken Fowler's solution for 6 months at age 12, developed jaundice and fatigue [bilirubin 6.6 mg/dL, ALT 110 U/L, Alk P 497 U/L], liver biopsy showing hepatic angiosarcoma). 6890767
Lüth H. The consequences of chronic arsenic poisoning among Moselle wine growers. Pathoanatomical investigations of post-mortem examinations performed between 1960 and 1977. J Cancer Res Clin Oncol 1983; 105: 173-82. (Arsenic was eliminated from pesticides in Germany in 1942, but residual toxicity persisted including high rates of cirrhosis and lung cancer [the most common cause of death] up to 25 years later). 6826638
Koshy A, Narang AP, Bhusnurmath SR. Hepatic arsenic in non-cirrhotic portal fibrosis. Toxicol Lett 1983; 19: 201. (Arsenic levels were elevated in livers from autopsies of patients with cirrhosis [81 µg], noncirrhotic portal hypertension [26 µg] and other liver diseases [56 µg] compared to controls [2 µg/100g], casting doubt on its role in non-cirrhotic portal hypertension). 6658826
Narang AP, Datta DV. Arsenic and liver. J Assoc Physicians India 1983 Feb; 31(2): 87-90. (Review of the problem of arsenic in the environment, in opium samples and Ayurvedic medicines and the effects of arsenic on the liver, including portal hypertension and its possible role in causing Indian childhood cirrhosis). 6885713
Kasper ML, Schoenfield L, Strom RL, Theologides A. Hepatic angiosarcoma and bronchioloalveolar carcinoma induced by Fowler's solution. JAMA 1984; 252: 3407-8. (67 year old man developed weakness, anorexia, ascites and jaundice [bilirubin 8.5 mg/dL, AST 34 U/L, Alk P 130 U/L] and gave a history of taking Fowler's solution for 8 years, 40 years earlier, autopsy showing hepatic angiosarcoma and bronchioalveolar carcinoma). 6094851
Okuda K, Kono K, Ohnishi K, Kimura K, Omata M, Koen H, Nakajima Y, et al. Clinical study of eighty-six cases of idiopathic portal hypertension and comparison with cirrhosis with splenomegaly. Gastroenterology 1984; 86: 600-10. (Description of 86 cases of idiopathic portal hypertension seen between 1965 and 1982 at Chiba University Hospital, 16 men and 70 women, ages 7 to 74 years, often presenting with variceal hemorrhage, ascites and abdominal pain, with splenomegaly and thrombocytopenia, but normal or near normal liver tests [ALT normal in 72% and Alk P in 49%], histology showing portal fibrosis and survival being better than matched control group with cirrhosis and portal hypertension). 6698361
Armstrong CW, Stroube RB, Rubio T, Siudyla EA, Miller GB Jr. Outbreak of fatal arsenic poisoning caused by contaminated drinking water. Arch Environ Health 1984; 39: 276-9. (Nine family members developed arsenic poisoning caused by contamination of well water [by pesticide], 5 developing renal injury and 4 hepatitis; the most common symptoms were vomiting and diarrhea, periorbital swelling, epistaxis and anemia followed by seizures, fever, rash and coma; 2 dying of heart and renal failure with sepsis). 6497443
Winship KA. Toxicity of inorganic arsenic salts. Adverse Drug React Acute Poisoning Rev 1984; 3: 129-60. (Review of the acute and chronic effects of arsenic exposure, both environmental and medicinal). 6397979
el Zayadi A, Khalil A, el Samny N, Hamza MR, Selim O. Hepatic angiosarcoma among Egyptian farmers exposed to pesticides. Hepatogastroenterology 1986; 33: 148-50. (14 Egyptian farmers were diagnosed with hepatic angiosarcoma at a single referral hospital between 1980 and 1984; 10 had a history of arsenic exposure). 3758905
Guha Mazumder DN, Chakraborty AK, Ghose A, Gupta JD, Chakraborty DP, Dey SB, Chattopadhyay N. Chronic arsenic toxicity from drinking tubewell water in rural West Bengal. Bull World Health Organ 1988; 66: 499-506. (Among 13 Indian patients [ages 15-50 years] with chronic arsenic skin toxicity, all had liver and 5 spleen enlargement, but routine liver tests were normal, while liver biopsies showed mild inflammation and fibrosis without cirrhosis; an epidemiological study of the patients' villages showed high levels of arsenic in the well water [2 mg/L] and frequent skin discoloration and hepatomegaly [both 93%], which were not found in villages with low arsenic levels in drinking water). 3262450
Mueller PD, Benowitz NL. Toxicologic causes of acute abdominal disorders. Emerg Med Clin North Am 1989; 7: 667-82. (Review of gastrointestinal toxicity of agents including iron, mercury and copper). 2663462
Piontek M, Hengels KJ, Borchard F, Strohmeyer G. [Noncirrhotic liver fibrosis after chronic arsenic poisoning]. Dtsch Med Wochenschr 1989; 114: 1653-7. German. (67 year old woman who was treated with Fowler's solution since childhood for psoriasis developed non-cirrhotic portal hypertension and recurrent variceal hemorrhage; bleeding episodes resolving after portal decompression surgery). 2806096
Poklis A, Saady JJ. Arsenic poisoning: acute or chronic? Suicide or murder? Am J Forensic Med Pathol 1990; 11: 226-32. (62 year old man developed intermittent bouts of abdominal pain, vomiting, dehydration and diarrhea with skin pigmentation and keratosis, neutropenia and peripheral neuropathy and on autopsy had elevated arsenic concentrations in hair and tissue; he being the 5th husband of an often widowed wife). 2220708
Nevens F, Fevery J, Van Steenbergen W, Sciot R, Desmet V, De Groote J. Arsenic and non-cirrhotic portal hypertension. A report of eight cases. J Hepatol 1990; 11: 80-5. (Among 47 patients [3 women, 4 men, ages 24-55 years] with non-cirrhotic portal hypertension seen over a 10 year period, 8 gave a history of taking Fowler's solution for psoriasis; all had esophageal varices and splenomegaly with normal liver tests and liver history showing portal fibrosis without cirrhosis; estimated intake was 3-27 grams, over 2 to 15 years, and clinical presentation 2 to 16 years later with massive variceal bleeding in 7 and ovarian cancer in 1). 2398270
Labadie H, Stoessel P, Callard P, Beaugrand M. Hepatic venoocclusive disease and perisinusoidal fibrosis secondary to arsenic poisoning. Gastroenterology 1990; 99: 1140-3. (38 year old alcoholic man underwent 3 liver biopsies for unexplained liver test abnormalities and during an admission for suspected self-inflicted arsenic poisoning, biopsies showed perisinusoidal fibrosis and sinusoidal dilatation, which subsequently resolved). 2394335
Salgado M, Sans M, Forns X, Bruguera M, Castells A, Navasa M, RodéJ. [Hepatic angiosarcoma: a report of a case associated with treatment with arsenic salts and a review of the literature]. Gastroenterol Hepatol 1995; 18: 132-5. Spanish. (63 year old man presented with hemoperitoneum, emergency laparotomy demonstrating a large hepatic angiosarcoma; the only known toxic exposure was a course of intravenous arsenic containing Neosalvarrsan at the age of 17, 45 years before presentation). 7621289
Upshaw CB Jr, Claiborne TS Jr. Medicinal arsenic poisoning: 27-year follow-up. South Med J 1995; 88: 892-3. (Letter with follow-up on patient who had non-cirrhotic portal hypertension after a 5 year course of arsenic therapy [Upshaw 1979], who subsequently had no further bleeding, but developed mildly abnormal liver tests and died from a farm accident 15 years later). 7631226
Loguercio C, De Girolamo V, Federico A, Feng SL, Cataldi V, Del Vecchio Blanco C, Gialanella G. Trace elements and chronic liver diseases. J Trace Elem Med Biol 1997; 11: 158-61. (Blood levels of chromium, manganese, cooper and rubidium were similar in patients with hepatitis C related cirrhosis as controls, but selenium and zinc levels were lower). 9442462
Hernáez-Zavala A, Del Razo LM, Aguilar C, GarcíVargas GG, Borja VH, CebriáME. Alteration in bilirubin excretion in individuals chronically exposed to arsenic in Mexico. Toxicol Lett 1998; 99: 79-84. (Among 51 persons chronically exposure to high arsenic levels in drinking water, serum direct bilirubin and alkaline phosphatase were mildly elevated with little or no change in ALT, AST or GGT). 9817078
Huang SY, Yang CH, Chen YC. Arsenic trioxide therapy for relapsed acute promyelocytic leukemia: an useful salvage therapy. Leuk Lymphoma 2000; 38: 283-93. (Review of arsenic trioxide as therapy of promyelocytic leukemia; despite a lack of controlled trials the authors conclude that it is useful as salvage therapy; liver dysfunction was reported in 8-46% of treated patients in 3 case series). 10830735
Jensen K. [Arsenic as an environmental problem]. Ugeskr Laeger 2000 Dec 4; 162 (49): 6672-5. Danish. (Review of contamination of ground and well water with arsenic that was particularly common in the well drilling in the Ganges delta during the 1960s). 11188053
Loguercio C, De Girolamo V, Federico A, Feng SL, Crafa E, Cataldi V, Gialanella G, et al. Relationship of blood trace elements to liver damage, nutritional status, and oxidative stress in chronic nonalcoholic liver disease. Biol Trace Elem Res 2001; 81: 245-54. (Analysis of trace element concentrations in 50 patients with chronic liver disease [39 with cirrhosis] and 10 controls found slight decreases in iron, zinc and selenium in patients with cirrhosis). 11575681
Guha Mazumder DN. Arsenic and liver disease. J Indian Med Assoc 2001 Jun; 99 (6): 311, 314-5, 318-20. (Clinical description of 248 Indian patients with chronic arsenic toxicity found hepatomegaly in 77%, splenomegaly 30%, ascites 2%; liver tests done in 93 found ALT elevations in 26% and Alk P 29%; liver biopsy done in 69 cases showed portal fibrosis in 91% and cirrhosis in 3%). 11678619
Guha Mazumder DN. Chronic arsenic toxicity: clinical features, epidemiology, and treatment: experience in West Bengal. J Environ Sci Health A Tox Hazard Subst Environ Eng 2003; 38: 141-63. (Clinical description of 248 Indian patients with chronic arsenic toxicity found hepatomegaly in 77%, splenomegaly 30%, ascites 2%; liver tests done in 93 found ALT elevations in 26% and Alk P 29%; liver biopsy done in 69 cases showed portal fibrosis in 91% and cirrhosis in 3%; in epidemiological studies, rates of hepatomegaly correlated with higher arsenic levels in drinking water [105] compared to controls [3%]). 12635824
Srivastava A, Peshin SS, Kaleekal T, Gupta SK. An epidemiological study of poisoning cases reported to the National Poisons Information Centre, All India Institute of Medical Sciences, New Delhi. Hum Exp Toxicol 2005; 24: 279-85. (Among 2719 calls to an Indian poisoning center over a 3 year period, 48 [2%] were for copper sulfate and 6 [<0.5%] for heavy metals including arsenic, lead, mercury and thallium). 16004194
De Capitani EM, Vieira RJ, Madureira PR, Mello SM, Kira CS, Soubhia PC, Toledo AS. Auditory neurotoxicity and hepatotoxicity after MSMA(monosodium methanarsenate) high dose oral intake. Clin Toxicol (Phila) 2005; 43: 287-9. (36 year old man took a suicidal overdose of the herbicide monosodium methanarsenate [MSMA] and rapidly developed nausea, vomiting and drowsiness, followed by deafness and abnormal liver tests [bilirubin 9.8 mg/dL, ALT 394 U/L, Alk P 327 U/L, creatinine 1.4 mg/dL] that mostly improved with dimercaprol chelation therapy [bilirubin 1.0 mg/dL, ALT 58 U/L, Alk P 377 U/L]). 16035206
Mukherjee A, Sengupta MK, Hossain MA, Ahamed S, Das B, Nayak B, Lodh D, et al. Arsenic contamination in groundwater: a global perspective with emphasis on the Asian scenario. J Health Popul Nutr 2006; 24: 142-63. (Overview of arsenic contamination in groundwater from published reports from 42 areas from 6 continents). 17195556
Mathews V, Desire S, George B, Lakshmi KM, Rao JG, Viswabandya A, Bajel A, et al. Hepatotoxicity profile of single agent arsenic trioxide in the treatment of newly diagnosed acute promyelocytic leukemia, its impact on clinical outcome and the effect of genetic polymorphisms on the incidence of hepatotoxicity. Leukemia 2006; 20: 881-3. (Among 83 patients with newly diagnosed acute promyelocytic leukemia who were treated with arsenic trioxide, 96% achieved remission and hepatotoxicity occurred in 29 [39%], but resolved despite continuing therapy in 21 and, of 8 who were rechallenged, only 1 had recurrence; toxicity was grade 4 [severe] in 8 patients, but none died from liver injury). 16525498
Kapaj S, Peterson H, Liber K, Bhattacharya P. Human health effects from chronic arsenic poisoning--a review. J Environ Sci Health A Tox Hazard Subst Environ Eng 2006; 41: 2399-428. (Thorough review of the complications of chronic arsenic in take). 17018421
Ahamed S, Kumar Sengupta M, Mukherjee A, Amir Hossain M, Das B, Nayak B, et al. Arsenic groundwater contamination and its health effects in the state of Uttar Pradesh(UP) in upper and middle Ganga plain, India: a severe danger. Sci Total Environ 2006; 370(2-3): 310-22. (Analysis of well water arsenic found high levels in 3 districts in Uttar Padesh with arsenical skin lesions in 20% of adults and 6% of children; no mention of liver related complications). 16899281
Chen Y, Parvez F, Gamble M, Islam T, Ahmed A, Argos M, Graziano JH, et al. Arsenic exposure at low-to-moderate levels and skin lesions, arsenic metabolism, neurological functions, and biomarkers for respiratory and cardiovascular diseases: review of recent findings from the Health Effects of Arsenic Longitudinal Study (HEALS) in Bangladesh. Toxicol Appl Pharmacol 2009; 239: 184-92. (Assessment of well water arsenic exposure and possible complications in Bangladesh, does not discuss hepatic side effects). 19371619
Islam K, Haque A, Karim R, Fajol A, Hossain E, Salam KA, Ali N, et al. Dose-response relationship between arsenic exposure and the serum enzymes for liver function tests in the individuals exposed to arsenic: a cross sectional study in Bangladesh. Environ Health 2011; 10: 64. (In a study of 200 Bangladesh residents, a positive association was found between higher drinking water arsenic levels [>50 vs 10-50 vs <10 µg/L] and higher serum enzyme levels [ALT 34 vs 27 vs 24 U/L and Alk P 108 vs 91 vs 83 U/L]). 21740555
Das N, Paul S, Chatterjee D, Banerjee N, Majumder NS, Sarma N, Sau TJ, Basu S, et al. Arsenic exposure through drinking water increases the risk of liver and cardiovascular diseases in the population of West Bengal, India. BMC Public Health 2012; 12: 639. (Comparison of 103 Bengali villagers with high arsenic drinking water exposure to 107 with low exposure found higher mean levels of ALT [37 vs 32 U/L] and Alk P [274 vs 217 U/L] in the higher arsenic exposed group). 22883023
Lin HJ, Sung TI, Chen CY, Guo HR. Arsenic levels in drinking water and mortality of liver cancer in Taiwan. J Hazard Mater 2013 Nov 15; 262: 1132-8. (Analysis of arsenic levels in drinking water and mortality rates for liver cancer between 1971 and 1990 in 1103 persons from 138 villages in Taiwan found a positive association with liver cancer rates and arsenic levels in water above 640 µg/L, but not at lower levels of exposure). 23352725
Hong YS, Song KH, Chung JY. Health effects of chronic arsenic exposure. J Prev Med Public Health 2014; 47: 245-52. (Review of the complications of chronic arsenic exposure including skin, lung, bladder, liver and prostate cancer, leukemia, neurologic effects, diabetes, skin conditions, cardiovascular disease and reproduction, but not liver disease or cirrhosis). 25284195
Burnett AK, Russell NH, Hills RK, Bowen D, Kell J, Knapper S, Morgan YG, et al.; UK National Cancer Research Institute Acute Myeloid Leukaemia Working Group. Arsenic trioxide and all-trans retinoic acid treatment for acute promyelocytic leukaemia in all risk groups (AML17): results of a randomised, controlled, phase 3 trial. Lancet Oncol 2015; 16: 1295-305. (Have). 26384238
Wang H, Liu Y, Wang X, Liu D, Sun Z, Wang C, Jin G, Zhang B, Yu S. Randomized clinical control study of locoregional therapy combined with arsenic trioxide for the treatment of hepatocellular carcinoma. Cancer 2015; 121: 2917-25. (Have). 26033499
Liu B, Huang JW, Li Y, Hu BS, He X, Zhao W, Zheng YB, et al. Arsenic trioxide transarterial chemoembolization with and without additional intravenous administration of arsenic trioxide in unresectable hepatocellular carcinoma with lung metastasis: a single-blind, randomized trial. J Cancer Res Clin Oncol 2015; 141: 1103-8. (Have). 25504506
Duncan A, Taylor A, Leese E, Allen S, Morton J, McAdam J. Homicidal arsenic poisoning. Ann Clin Biochem 2015; 52 (Pt 4): 510-5. (Have). 25344454
Goel A, Christudoss P, George R, Ramakrishna B, Amirtharaj GJ, Keshava SN, Ramachandran A, et al. Arsenicosis, possibly from contaminated groundwater, associated with noncirrhotic intrahepatic portal hypertension. Indian J Gastroenterol 2016; 35: 207-15. (Have). 27225799
Hsu LI, Wang YH, Hsieh FI, Yang TY, Wen-Juei Jeng R, Liu CT, Chen CL, Hsu KH, Chiou HY, Wu MM, Chen CJ. Effects of arsenic in drinking water on risk of hepatitis or cirrhosis in persons with and without chronic viral hepatitis. Clin Gastroenterol Hepatol 2016; 14: 1347-55.e4. (Have). 27060428
Cappelletti R, Ceppi M, Claudatus J, Gennaro V. Health status of male steel workers at an electric arc furnace (EAF) in Trentino, Italy. J Occup Med Toxicol 2016; 11: 7. (Have). 26900394
Li Y, Ye F, Wang A, Wang D, Yang B, Zheng Q, Sun G, Gao X. Chronic Arsenic Poisoning probably caused by arsenic-based pesticides: findings from an investigation study of a household. Int J Environ Res Public Health 2016; 13. pii: E133. (Have). 26784217
Lin YC, Lian IB, Kor CT, Chang CC, Su PY, Chang WT, Liang YF, Su WW, Soon MS. Association between soil heavy metals and fatty liver disease in men in Taiwan: a cross sectional study. BMJ Open 2017; 7: e014215. (Have). 28115335
Hu HT, Yao QJ, Meng YL, Li HL, Zhang H, Luo JP, Guo CY, Geng X. Arsenic trioxide intravenous infusion combined with transcatheter arterial chemoembolization for the treatment of hepatocellular carcinoma with pulmonary metastasis: Long-term outcome analysis. J Gastroenterol Hepatol 2017; 32: 295-300. (Have). 27517972
Kumthekar P, Grimm S, Chandler J, Mehta M, Marymont M, Levy R, Muro K, et al. A phase II trial of arsenic trioxide and temozolomide in combination with radiation therapy for patients with malignant gliomas. Neurooncol 2017; 133: 589-94. (Have). 28510787

## OTHER REFERENCE LINKS

1. Recent References on Arsenic: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(fluoxetine)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Arsenic: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=fluoxetine)